# Reserpine

## OVERVIEW

### Introduction

Reserpine is an oral antihypertensive medication that acts through inhibitor of alpha-adrenergic transmission and was one of the first antihypertensive agents introduced into clinical practice. Despite widescale use for many years, reserpine has not been shown to cause clinically apparent liver injury.

### Background

Reserpine (re ser' peen) was one of the first antihypertensive agents developed for use in humans. It is an alkaloid extract of the Rauwolifia serpentine (thus its name) which is a climbing shrub found in India. Reserpine is thought to act by binding to adrenergic storage vesicles in neurons, inhibiting their capacity to concentrate and store norepinephrine and dopamine. The antihypertensive effect of reserpine correlates with the depletion of sympathetic amines in both the central nervous system and periphery. Reserpine is effective in lowering blood pressure and can be used alone or in combination with other antihypertensive medications. Reserpine was approved for use in the United States in 1955 but is currently rarely used, largely because of its central nervous system effects and the availability of many better tolerated and more potent antihypertensive medications. Reserpine continues to be available in generic forms as tablets of 0.1 and 0.25 mg. The typical maintenance dose in adults is 0.05 to 0.25 mg once daily. Side effects are common and include sedation, difficulty concentrating, fatigue, depression, dry mouth, headaches, dizziness, postural hypotension, male impotence and gastrointestinal upset.

### Hepatotoxicity

Serum aminotransferase elevations during reserpine therapy are uncommon, but specific rates of such elevations in comparison to placebo treatment have not been reported. Despite many decades of use, reserpine has been implicated in few instances of clinically apparent acute liver injury, and none of them were particularly convincing. Published cases were marked by jaundice and abdominal pain arising a year after starting reserpine, but in combination with other known hepatotoxic agents (dihydrazine, phenobarbital, quinidine). The few cases that have been reported were self-limiting and resolved within a few months of stopping therapy. The last case of suspected reserpine associated liver injury was published more than 50 years ago.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Reserpine is metabolized by the cytochrome P450 (CYP) system to a major degree but neither induces or inhibits CYP activity, which may account in part for its relative lack of hepatotoxicity.

Drug Class: Antihypertensive Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Reserpine – Generic

DRUG CLASS

Antihypertensive Agent

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=reserpine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Reserpine | 50-55-5 | C33-H40-N2-O9 | Reserpine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 21 May 2018

Zimmerman HJ. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 639-71. (Expert review of hepatotoxicity published in 1999; reserpine rarely causes significant liver injury, only two case reports having been published despite its wide use).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs: antihypertensives. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of hypertensive agents; reserpine is not discussed).
Michel T, Hoffman BB. Therapy of myocardial ischemia and hypertension. In, Brunton LL, Lazo JS, Parker KL, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 745-88. (Textbook of pharmacology and therapeutics; “reserpine was the first drug that was found to interfere with the function of the sympathetic nervous system in human beings, and its use began the modern era of effective pharmacotherapy of hypertension”).
Nagler A, Enat R. [Liver damage due to reserpine hypersensitivity]. Harefuah 1984; 107: 130-1. Hebrew. (52 year old woman developed jaundice 1 year after starting combination of dihydralazine and reserpine for hypertension [bilirubin 8 mg/dL, AST 480 U/L, Alk P 263 U/L], resolving within 1 month of stopping and recurring after 1 month of restarting both; may have been due to dihydralazine, but positive in vitro reactions occurred with reserpine alone). 6510817
Moeckel W. [On the clinical picture of jaundice with intrahepatic cholestasis caused by drugs]. Med Klin 1965; 60: 294-8. German. (Five cases of drug induced cholestatic hepatitis; case 3 was 66 year old man who developed jaundice after being on reserpine, phenobarbital and quinidine for one year [bilirubin 17.4 mg/dL, Alk P 2 times ULN, eosinophils 12%]; while phenobarbital and quinidine can also cause liver injury, the case was attributed to reserpine on the basis of in vitro stimulation tests). 14258124
Drugs for hypertension. Treat Guidel Med Lett 2009; 7: 1-10. (Brief overview of currently available drugs for hypertension with guidelines on their use and information on prices and toxicities: “Reserpine is an effective antihypertensive, but is seldom used now because in doses much higher than currently recommended, it can cause severe depression”). 19107095
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases; no cases were attributed to reserpine). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 39 [4%] were due to antihypertensive agents but none were believed to be due to reserpine). 25754159
Drugs for hypertension. Med Lett Drugs Ther 2017; 59 (1516): 41-8. (Concise overview of the currently available drugs for hypertension with guidelines on their use and information on prices and toxicities; reserpine is not discussed). 28263286

## OTHER REFERENCE LINKS

1. Recent References on Reserpine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(reserpine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Reserpine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Reserpine)